# Chelating Agents

## OVERVIEW

Chelating agents are used to reduce blood and tissue levels of injurious heavy metals. Chelating agents are generally classified based upon the target heavy metal – iron, copper, mercury and lead being the major targets. Some chelating agents have a high degree of specificity for the target metal, while others chelate multiple agents. Specificity is important in regard to safety, as chelation of other metals or minerals may lead to serious side effects, for instance, lowering of calcium or phosphate levels as occurs with EDTA. The most important step in management of excessive heavy metal accumulation or poisoning is to avoid or eliminate the source of the exposure. Pharmacological interventions are complementary, but are effective and can be life saving.

The iron chelating agents currently in use include deferoxamine, deferasirox and deferiprone, all of which are highly specific for iron and have little or no effect on levels of copper, lead, calcium, magnesium or phosphate. Deferasirox and deferiprone can be administered orally, whereas deferoxamine requires parenteral administration.

The copper chelating agents in current use include penicillamine, trientine and dimercaprol. These agents are used largely to treat Wilson disease, the complications of which are caused by excessive body copper accumulation. Dimercaprol (also known as British anti-Lewisite [BAL]) must be given intravenously and is generally used only for acute or advanced symptomatic Wilson disease. It is also effective in lowering levels of other heavy metals including arsenic and mercury. Penicillamine and trientine are orally available and are the mainstays of prevention and therapy of Wilson disease. Trientine is generally better tolerated than penicillamine, which has many difficult side effects including acute liver injury. Nevertheless, penicillamine appears to be more effective in the initial management of symptomatic Wilson disease and is preferred as a first line therapy. Zinc is also used to treat Wilson disease, but it appears to act by inhibition of absorption of copper from the diet rather than chelation of copper from serum or tissue.

The lead and other heavy metal chelators include succimer (dimercaptonol), dimercaprol (BAL), and ethylenediaminetetraacetic acid (EDTA). Succimer is orally available and appears to be more effective and better tolerated that the other therapies, which require intravenous administration. These agents are also used for arsenic, mercury and cadmium poisoning.

The chelating agents are rare causes of liver injury, the only agent convincingly linked to causing idiosyncratic acute liver injury with jaundice being penicillamine which usually causes of an immunoallergic, mostly cholestatic hepatitis with a short incubation period.

The following chelating agents are discussed individually or jointly in LiverTox:

- Arsenic Chelators
  - Dimercaprol
- Copper Chelators (for Wilson Disease)
  - Dimercaprol
  - Penicillamine
  - Trientine
  - Zinc
- Iron Chelators
  - Deferasirox
  - Deferiprone
  - Deferoxamine
- Lead Chelators
  - Dimercaprol
  - EDTA [not in LiverTox]
  - Succimer
- Mercury Chelators
  - Dimercaprol

## ANNOTATED BIBLIOGRAPHY

References updated: 23 January 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 includes discussion of penicillamine and deferoxamine).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1872-76. (Textbook of pharmacology and therapeutics).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 2 cases [0.2%] were attributed to chelating agents, one to penicillamine [acute icteric hepatitis arising within few weeks of starting penicillamine for scleroderma] and one to deferasirox [asymptomatic ALT elevations without jaundice which resolved rapidly with stopping, but recurred with rechallenge]). 25754159